# Chinese and other Asian Herbal Medicines

## OVERVIEW

Among the more than 7000 Chinese herbal medications, only a few have been linked to episodes of clinically apparent liver injury, most commonly mentioned being Ba Jiao Lian, Chi R Yun, Jin Bu Huan, Ma Huang/Ephedra, and Shou Wu Pian. Many of these are mixtures of herbs and the composition can vary considerably despite an identical name. In other instances, the composition of the herbal mixture is totally unknown. Traditional Chinese herbal medicines are widely used in Asian communities throughout the world for a broad array of conditions. Many of these are harmless or have only minor and transient adverse effects. A few can cause hepatic injury when given in high concentrations, and some even when used in recommended doses.

### Approach to Hepatotoxicity in Patients Taking an Herbal Medicine

When evidence of liver injury arises in a patient taking a traditional herbal medication, the appropriate response is to stop the agent and attempt to identify its nature and components. A major problem is that multiple herbs are often being taken and their exact nature and even name may not be known. The herbal products are often poorly labeled as to their composition and they may be mislabeled or contaminated with toxins, bacteria, metals or even conventional, synthetic or semisynthetic medications such as nonsteroidal antiinflammatory agents, corticosteroids, fibrates, or statins. It is helpful to collect the residual pills or extract as they may be helpful if identification is necessary. Characterization of the clinical phenotype or pattern of hepatic injury is also helpful in identifying the specific agent causing the injury. For instance, comfrey and plant pyrrolizidine alkaloids are typically associated with acute sinusoidal obstruction syndrome, whereas germander, greater celandine, usnic acid, Jin Bu Huan, Shou Wu Pian and Ma Huang (ephedra) present typically with an acute viral hepatitis-like syndrome. Pennyroyal oil and Chi R Yun (Breynia) cause acute hepatic necrosis, often accompanied by signs and symptoms of injury to other organs, such as the gastrointestinal tract, lungs, kidneys or central nervous system. Androgenic steroids cause bland cholestasis, characterized by deep jaundice and pruritus with minimal elevations in serum aminotransferase and alkaline phosphatase levels. In all situations, other causes of acute liver injury need to be excluded.

Specific Chinese and other Asian herbal medications implicated in liver injury include: Ba Jiao Lian* (Dysosma pleianthum), Bol Gol Zhee (Fructus psoraleae), Chi R Yun* (Breynia officinalis), Jin Bu Huan* (Lycopodium serratum), Ma Huang (Ephedra)*, Sho Saiko To*, and Shou Wu Pian* (Polygonum multiflorum). However, in many situations, the specific herbal product that is responsible for the liver injury is unclear and the injury ascribed to "Chinese Herbs" without specifying which.

References are given with each specific agent (*a drug record is in LiverTox), and selected general references to hepatotoxicity of miscellaneous and unspecified Chinese and Asian herbs are given in the Annotated Bibliography below.

Drug Class: Herbal and Dietary Supplements

Herbals in the Subclass Chinese and Other Asian Herbal Medicines: Ba Jiao Lian, Bol Gol Zhee, Chi R Yun, Jin Bu Huan, Ma Huang/Ephedra, Polygonum Multiflorum, Sho Saiko To and Dai Saiko To

## ANNOTATED BIBLIOGRAPHY

References updated: 25 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Chinese herbal products and teas are discussed generally without focus on any specific product or herb).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; traditional Chinese and other Asian herbal medicines and teas are discussed, including Ma Huang, Shou Wu Pian, Ba Jiao Lian, Jin Bu Huan, Breynia and Syo-Saiko-To).
PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007. (Compilation of short monographs on herbal medications and dietary supplements including sections on Ma Huang and other Chinese herbals).
Mokhobo KP. (1976). Herb use and necrodegenerative hepatitis. S Afr Med J. (12 African patients from Lesotho, ages <5 to 46 years, presented with ascites, edema or jaundice after taking herbal medications, toxic herb most likely Senecio species; 7 died and two others had cirrhosis and chronic symptoms).
Sinniah D, Baskaran G. (1981). Margosa oil as a cause of Reye’s syndrome. Lancet. (13 Malaysian children with margosa oil poisoning, with onset of vomiting within a few minutes of taking the herbal medicine, presented with drowsiness and metabolic acidosis, liver tests being usually normal, but liver biopsy showing steatosis of liver and renal tubules with mitochondrial damage suggestive of Reye syndrome).
Sinniah D, Baskaran G, Looi LM, Leong KL. (1982). Reye-like syndrome due to margosa oil poisoning: report of a case with postmortem findings. Am J Gastroenterol. (4 month old Indian female developed vomiting 1 hour after second ingestion of margosa oil [for cough], with drowsiness and acidosis [pH 6.8, bilirubin 0.2 mg/dL, AST 170 U/L, ALT 44 U/L, CPK 3180 U/L, prothrombin 16%], liver biopsy on day 5 showing microvesicular fat and mitochondrial abnormalities; died of cerebral edema on day 10).
(1984). Editorial. Pyrrolizidine alkaloids. Lancet. (Plants have evolved poisons that are toxic to insects, but can also cause hepatic venoocclusive disease in grazing animals and in humans who ingest them in teas and herbal medications: “a disastrous discontinuity of tradition”).
Ridker PM, Ohkuma S, McDermott WV, Trey C, Huxtable RJ. (1985). Hepatic veno-occlusive disease associated with the consumption of pyrrolizidine-containing dietary supplements. Gastroenterology. (49 year old woman developed ascites and edema 6 months after starting comfrey tea and capsules, requiring portocaval shunt and having slow improvement after stopping).
Kumana CR, Ng M, Lin HJ, Ko W, Wu PC, Todd D. (1985). Herbal tea induced hepatic veno-occlusive diseases; quantification of toxic alkaloid exposure in adults. Gut. (Four young women brewed Indian herbal tea to treat psoriasis and 3 developed ascites from sinusoidal obstruction syndrome 19-45 days later [bilirubin 0.6, 0.6 and 3.3 mg/dL, ALT 63, 122 and 69 U/L], one dying of hepatic failure; analysis of tea revealed pyrrolizidine alkaloids).
Culvenor CCJ. (1985). Pyrrolizidine alkaloids: some aspects of the Australian involvement. Trends Pharmacol Sci. (Presence of pyrrolizidine alkaloids in several common Australian weeds is a health hazard to livestock and humans; these include Heliotropium europaeum, Echium plantagineum, Senecio and Crotalaria species).
Mizoguchi Y, Miyajima K, Sakagami Y, Yamamoto S. (1986). Nippon Naika Gakkai Zasshi. (A 27 year old developed jaundice 6 weeks after taking Kinshigan, a Kampo herb with rapid recovery upon stopping, but recurring with a more severe course 2 weeks after restarting [bilirubin 28.5 mg/dL, ALT 166 U/L, Alk P 1.5 times ULN, 1% eosinophils]; among 18 ingredients, Scutellariae radix).
Satake I, Maeda M, Koyama W, Sakamoto S, Koizumi S, Kanayama M. (1986). A case of hepatic injury caused by an herb drug. Acta Hepatol Jpn.
Koga Y, Yoshida I, Kimura A, Yoshino M, Yamashita F, Sinniah D. (1987). Inhibition of mitochondrial functions by margosa oil: possible implications in the pathogenesis of Reye's syndrome. Pediatr Res. (Studies of isolated rat mitochondria demonstrated that margosa oil is a mitochondrial toxin, uncoupling respiratory chain enzymes and depleting ATP).
Sinniah R, Sinniah D, Chia LS, Baskaran G. (1989). Animal model of margosa oil ingestion with Reye-like syndrome. Pathogenesis of microvesicular fatty liver. J Pathol. (In mice, margosa oil causes rapid onset of mitochondrial injury, steatosis and glycogen depletion).
Georgiou M, Sianidou L, Hatzis T, Papadatos J, Koutselinis A. (1988). Hepatotoxicity due to Atractylis gummifera-L. J Toxicol Clin Toxicol. (7 year old Greek child developed abdominal pain, vomiting and progressive obtundation 2 days after being given an extract made from roots of Atractylis gummifera, dying in coma 8 days later [bilirubin rising to 9.8 mg/dL, ALT 6000 U/L], autopsy showing massive hepatic necrosis without steatosis).
MacGregor FB, Abernethy VE, Dahabra S, Cobden I, Hayes PC. (1989). Hepatotoxicity of herbal remedies. BMJ. (Four cases of hepatitis attributed to herbals, all women, ages 41-57, developed jaundice 2 to 8 weeks after starting herbals for stress [“Neurelax” and “Kalms”] believed to contain skullcap and/or valerian [bilirubin 13.5-28.3 mg/dL, ALT 293-1165 U/L, Alk P 97-730 U/L], resolving 2-19 months after stopping).
Carlsson C. (1990). Herbs and hepatitis. Lancet. (Analysis of laboratory results from 395 patients found higher average ALT levels among 53 patients taking herbals [55 U/L] than among those who did not [12 U/L]).
Allen BR, Parkinson R, Hollman A, Jones R, Harper JI. (1990). Davies, Pollock I, Steel HM. Chinese herbs for eczema (letters). Lancet. (Series of letters concerning use of Chinese herbs for eczema; Allen pointing out the adulteration with corticosteroids; Hollman requesting the names of the herbs included in the mix; Harper providing a list of the herbs in the mixture; finally Davies describing a 9 year old girl who developed jaundice after taking this herbal mixture for 6 months [bilirubin 7.9 mg/dL, ALT 1950 U/L, Alk P 379 U/L], resolving within 2 months of stopping and recurring within one month of restarting).
Marutani K, Matsuo S, Nishijima T, Watanobe T, Ishida Y, Sasaki K, Kameda C, Itoh S. (1990). Light and electron microscopic findings in the liver of five patients with syo-saiko-to-induced hepatitis. Jpn J Gastroenterol.
Beuers U, Spengler U, Pape GR. (1991). Hepatitis after chronic abuse of senna. Lancet. (26 year old nurse taking high doses of senna alkaloids developed jaundice and pruritus [bilirubin not given, ALT 303 U/L, Alk P 227 U/L], resolving within a few weeks of stopping and recurring upon restarting [ALT >280 U/L]).
Miskelly FG, Goodyer LI. (1992). Hepatic and pulmonary complications of herbal medicines. Postgrad Med J. (77 year old woman developed fatigue followed by jaundice 6 months after starting a herbal product with comfrey and skullcap [bilirubin 3.5 mg/dL, AST 520 U/L, Alk P 390 U/L], resolving within 6 months of stopping).
Graham-Brown R. (1992). Toxicity of Chinese herbal remedies. Lancet. (51 year old man took unknown Chinese herbs for psoriasis for 8 weeks and developed abnormal liver tests [bilirubin 1.6 mg/dL, ALT 2034 U/L, Alk P 348 U/L], resolving rapidly upon stopping).
Perharic-Walton L, Murray V. (1992). Toxicity of Chinese herbal remedies. Lancet. (28 year old woman developed jaundice 3-4 months after starting Chinese herbs for eczema, resolving upon stopping, but recurring with acute liver failure 2-3 weeks after restarting; the mixture containing 8 different herbal components).
Kao WF, Hung DZ, Tsai WJ, Lin KP, Deng JF. (1992). Podophyllotoxin intoxication: toxic effect of Bajiaolian in herbal therapeutics. Hum Exp Toxicol. (5 patients with Bajiaolian toxicity presenting with nausea, diarrhea, abdominal pain, abnormal liver tests [bilirubin normal, ALT 43-66 U/L, AST 52-183, Alk P usually normal], thrombocytopenia, sensory and motor neuropathy consistent with podophyllotoxin intoxication).
Sheehan MP, Atherton DJ. (1994). One year follow-up of children with atopic eczema treated with traditional Chinese medicinal plants. Br J Dermatol. (Among 37 children with eczema treated with Chinese herbs for up to 12 months, 2 developed asymptomatic AST elevations [315 and 586 U/L] with normal bilirubin [0.4 and 1.1 mg/dL], resolving within 8 weeks of stopping).
Eisenberg DM, Kessler RC, Foster C, Norlock FE, Calkins DR, Delbanco TL. (1993). Unconventional medicine in the United States. Prevalence, costs, and patterns of use. N Engl J Med. (Among 1539 adults interviewed by telephone, 34% used an unconventional therapy during the previous 12 months, including 3% using herbal medicines).
Centers for Disease Control and Prevention (CDC). (1993). Jin bu huan toxicity in children--Colorado, 1993. MMWR Morb Mortal Wkly Rep. (3 children, ages 13, 23 and 30 months, ingested 7, 17 and 60 tablets of Jin Bu Huan, developing lethargy and abnormal breathing within 30-60 minutes, responding rapidly to gastric lavage, activated charcoal and a cathartic, no mention of liver injury).
Centers for Disease Control and Prevention (CDC). (1993). Jin bu huan toxicity in adults--Los Angeles, 1993. MMWR Morb Mortal Wkly Rep. (3 women, ages 24, 45 and 66 years, taking Jin Bu Huan for insomnia for 2 to 4 months developed nausea, fatigue, pruritus and jaundice [bilirubin 0.7, 28.0 and 3.4 mg/dL, ALT 786, 1468 and 1308 U/L, Alk P 169, 133 and 225 U/L], resolving in 3-9 weeks upon stopping; analysis showed levo-tetrahydropalmatine which is not present in the plant claimed on the label [Polygala chinensis]).
Perharic L, Shaw D, Colbridge M, House I, Leon C, Murray V. (1994). Toxicological problems resulting from exposure to traditional remedies and food supplements. Drug Saf. (Retrospective and prospective survey identified 1070 enquires following exposure to herbal products, including 4 cases of liver injury from Chinese herbs, Psoralea coryliflora, valerian and skullcap).
Pillans PI, Eade MN, Massey RJ. (1994). Herbal medicine and toxic hepatitis. N Z Med J. (37 year old woman with psoriasis developed fatigue 13 days after starting Chinese herbs [bilirubin 0.6 rising to 7.9 mg/dL, ALT 243 to 2300 U/L, Alk P 234 to 380 U/L], with resolution within 7 weeks of stopping).
Caldwell SH, Feeley JW, Wieboldt TF, Featherston PL, Dickson RC. (1994). Acute hepatitis with use of over-the-counter herbal remedies. Va Med Q. (53 year old woman developed jaundice 4 weeks after starting an herbal for sleep [containing skullcap and valerian: 4 capsules nightly, with bilirubin 9 mg/dL, ALT 1208 U/L, Alk P 298 U/L, protime 13.5 sec], resolving in 3 months: Case 1 for skullcap).
Woolf GM, Petrovic LM, Rojter SE, Wainwright S, Villamil FG, Katkov WN, Michieletti P, et al. (1994). Acute hepatitis associated with the Chinese herbal product Jin Bu Huan. Ann Intern Med. (Seven adults developed hepatotoxicity due to Jin Bu Huan; 6 women and 1 man, ages 24 to 66 years, taking Jin Bu Huan for 7 to 52 weeks developed fever, fatigue, nausea, and pruritus with [n=3] or without jaundice [peak bilirubin 0.4 to 28.0 mg/dL, ALT 192 to 2149 U/L, Alk P 60 to 552 U/L], resolving in 2 to 30 weeks; this series included cases described by Woolf [1993]).
Delbanco TL. (1994). Bitter herbs: mainstream, magic and menace. Ann Intern Med. (Editorial accompanying Woolf [1994] regarding Jin Bu Huan Anodyne Tablets which were widely available before their withdrawal because of hepatotoxicity which was possibly caused by a contaminant).
Perharic L, Shaw D, Leon C, De Smet PA, Murray VS. (1995). Possible association of liver damage with the use of Chinese herbal medicine for skin disease. Vet Hum Toxicol. (9 reports of liver damage from a Chinese herbal medicine for skin conditions were made to London poisoning unit; 7 women and one man, ages 23 to 56 years, taking herbs for 2 weeks to 10 months [intermittently], 1 with fatal acute liver failure, 3 with jaundice [ALT usually very high with near normal Alk P], two had positive rechallenge; analysis showed 23 ingredients and 40 plant species, animal parts and a fungus).
Itoh S, Marutani K, Nishijima T, Matsuo S, Itabashi M. (1995). Liver injuries induced by herbal medicine sho-saiko-to (xiao-chai-hu-tang). Dig Dis Sci. (4 cases, 42 to 58 year old women, taking Syo Saiko To for 3-7 weeks, developed liver test elevations, 2 with jaundice, 2 with recurrence on restarting [peak ALT 135 to 1335 U/L], with resolution within 2 to 3 months of stopping).
Kane JA, Kane SP, Jain S. (1995). Hepatitis induced by traditional Chinese herbs: possible toxic components. Gut. (Two patients, 39 and 61 year old women, developed jaundice 2 and 6 months after starting Chinese herbs for skin conditions [bilirubin 26 and 12.9 mg/dL, ALT 2440 and AST >1000 U/L, Alk P 261 and 311 U/L], resolving within 2-3 months of stopping, one had recurrence on restarting; analysis of products identified multiple plant species).
Vautier G, Spiller RC. (1995). Safety of complementary medicines should be monitored. BMJ. (32 year old man took Chinese herbal medication and 5 weeks later developed jaundice followed by acute liver failure and death; few details given, but product contained Dictamnus dasycarpus).
Centers for Disease Control and Prevention (CDC). (1995). Unexplained severe illness possibly associated with consumption of Kombucha tea--Iowa, 1995. MMWR Morb Mortal Wkly Rep. (Two patients from a rural town in Iowa developed severe unexplained illness [lactic acidosis and cardiopulmonary collapse] after taking Kombucha tea for 2 months; cause was not identified).
Perron AD, Patterson JA, Yanofsky NN. (1995). Kombucha “mushroom” hepatotoxicity. Ann Emerg Med. (53 year old man developed fever, rash and abdominal cramping 4 weeks after starting and 2 weeks after stopping Kombucha tea [bilirubin normal, ALT 285 U/L, Alk P 168 U/L], resolving 1 month later).
Horowitz RS, Feldhaus K, Dart RC, Stermitz FR, Beck JJ. (1996). The clinical spectrum of Jin Bu Huan toxicity. Arch Intern Med. (6 cases: 3 in children, 2 girls and 1 boy, ages 13, 19 and 30 months, with accidental ingestion of 5, 17 and 60 tablets of Jin Bu Huan presenting within hours with lethargy, ataxia, coma, respiratory depression, but with rapid recovery without sequelae; 3 cases in adults, 50, 55 and 70 year old women, becoming symptomatic 1, 2 and 24 weeks after starting Jin Bu Huan, 2 with marked ALT elevations but normal bilirubin, 1 with jaundice and ALT 1500 U/L, abnormalities persisting while herb was continued intermittently and falling to normal within 2 months of stopping).
Kaptchuk TJ. (1995). Acute hepatitis associated with Jin Bu Huan. Ann Intern Med. (Letter in response to Woolf [1994], arguing that the liver injury was not due to Jin Bu Huan, but rather another plant contaminant with high concentrations of the alkaloid, L-tetrahydropalmatine).
Nadir A, Agrawal S, King PD, Marshall JB. (1996). Acute hepatitis associated with the use of a Chinese herbal product, ma-huang. Am J Gastroenterol. (33 year old woman developed nausea within days of starting Ma Huang for weight loss followed at 3 weeks by jaundice [bilirubin 4.5 rising to 8 mg/dL, ALT 832 U/L, Alk P 178 U/L, ANA 1:160, asterixis], resolving within 4 weeks of stopping).
But PP, Tomlinson B, Lee KL. (1996). Hepatitis related to the Chinese medicine Shou-wu-pian manufactured from Polygonum multiflorum. Vet Hum Toxicol. (31 year old woman from Hong Kong developed jaundice several weeks after starting Shou Wu Pian for hair loss [bilirubin 4.0 rising to 6.1 mg/dL, ALT 870 U/L, Alk P 108 U/L], resolving within 3 weeks of stopping).
De Smet PA, Van den Eertwegh AJ, Lesterhuis W, Stricker BH. (1996). Hepatotoxicity associated with herbal tablets. BMJ. (69 year old woman developed jaundice six weeks after starting herbal tablets “Venencapsan” prepared locally from horse chestnut leaf, milfoil, celandine, sweet clover, milk thistle and dandelion root, recurring on reexposure [bilirubin 1.6 and 4.7 mg/dL, ALT 244 and 1004 U/L, Alk P 229 and 250 U/L], resolving rapidly on stopping).
Huang WF, Wen KC, Hsiao ML. (1997). Adulteration by synthetic therapeutic substances of traditional Chinese medicines in Taiwan. J Clin Pharmacol. (Prospective analysis of 2609 samples of herbal medications in Taiwan found adulteration in 24%, major adulterants being caffeine, acetaminophen, nonsteroidal antiinflammatory agents, corticosteroids, antihistamines, salicylates, benzodiazepines and barbiturates).
Kamiyama T, Nouchi T, Kojima S, Murata N, Ikeda T, Sato C. (1997). Autoimmune hepatitis triggered by administration of an herbal medicine. Am J Gastroenterol. (55 year old woman with chronic hepatitis developed jaundice one month after starting Dai Saiko To [bilirubin 11.2 mg/dL, ALT 390 U/L, ANA 1:2560], responding rapidly to prednisone therapy).
Matsuda R, Takahashi D, Chiba E, Kawana I, Tomiyama M, Ebira H, Ikegami T, et al. (1997). Nihon Shokakibyo Gakkai Zasshi. (65 year old man developed dyspnea and interstitial pneumonitis with abnormal liver tests 4 weeks after starting Dai Saiko To for autoimmune dermatitis, stopping at 6 weeks [bilirubin 1.2 mg/dL, ALT 675 U/L, Alk P 1070 U/L], resolving within a month of stopping).
Shaw D, Leon C, Kolev S, Murray V. (1997). Traditional remedies and food supplements. A 5-year toxicological study(1991-1995). Drug Saf. (Five year experience of a Medical Toxicology Unit in London including 1297 enquiries including 37 for liver injury; 9 cases described, 5 due to valerian).
Levi M, Guchelaar HJ, Woerdenbag HJ, Zhu YP. (1998). Acute hepatitis in a patient using a Chinese herbal tea—a case report. Pharm World Sci. (49 year old man developed jaundice 2 weeks after starting an herbal mixture for eczema [bilirubin 2.9 mg/dL, ALT 716 U/L, Alk P 78 U/L], with near normal values 3 months after stopping).
Picciotto A, Campo N, Brizzolara R, Giusto R, Guido G, et al. (1998). Chronic hepatitis induced by jin bu huan. J Hepatol. (49 year old man found to have raised serum enzymes while taking Jin Bu Huan unbeknownst to his physicians [bilirubin 0.8 mg/dL, ALT 274 U/L, Alk P normal], which persisted for 10 months, biopsy showing chronic hepatitis and bridging fibrosis, liver tests falling to normal upon stopping herbal).
Hullar TE, Sapers BL, Ridker PM, Jenkins RL, Huth TS, Farraye FA. (1999). Herbal toxicity and fatal hepatic failure. Am J Med. (28 year old developed jaundice after taking skullcap and Pau d’arco for 6 months for his multiple sclerosis [bilirubin 29.0 mg/dL, ALT 3917 U/L, Alk P 106 U/L, protime 20 seconds, ANA 1:640], progressing to liver failure and liver transplant 5 weeks later, dying shortly thereafter; explant showed sinusoidal obstruction syndrome).
Melchart D, Linde K, Hager S, Kaesmayr J, Shaw D, Bauer R, Weidenhammer W. (1999). Monitoring of liver enzymes in patients treated with traditional Chinese drugs. Complement Ther Med. (Among 1450 patients with laboratory test results at the beginning and end of a hospital admission who were receiving traditional Chinese medicines, 3.1% had de novo abnormality of ALT, 1% with greater than two fold elevation, but other causes were likely in most cases).
Melchart D, Linde K, Weidenhammer W, Hager S, Shaw D, Bauer R. (1999). Liver enzyme elevations in patients treated with traditional Chinese medicine. JAMA. (Among 1507 patients treated with traditional Chinese herbs who had laboratory test results at the beginning and end of a hospital admission, 14 [0.9%] had greater than two fold elevation in ALT, 2 with symptoms, but other causes were likely in most cases).
Brinkhaus B, Lindner M, Schuppan D, Hahn EG. (2000). Chemical, pharmacological and clinical profile of the East Asian medical plant Centella asiatica. Phytomedicine. (Centella asiatica is an ancient medicinal herb, native to China and Southeast Asia, which contains pentacyclic triterpene derivatives and has been used for venous insufficiency and wound healing and as a sedative, analgesic, antidepressive, antimicrobial and immunomodulatory agent; toxicity includes allergic reactions and mild gastrointestinal upset).
Brent J. (1999). Three new herbal hepatotoxic syndromes. J Toxicol Clin Toxicol. (Summary of literature on hepatotoxicity of 3 herbals recently described including germander, Jin Bu Huan and chaparral).
Nadir A, Reddy D, Van Thiel DH. (2000). Cascara sagrada-induced intrahepatic cholestasis causing portal hypertension: case report and review of herbal hepatotoxicity. Am J Gastroenterol. (48 year old man developed jaundice 3 days after starting Cascara sagrada [bilirubin 11.8 mg/dL, ALT 999 U/L, Alk P 309 U/L, ANA 1: 640], developing ascites, but recovering in 3 months).
Shimizu I. (2000). Sho-saiko-to: Japanese herbal medicine for protection against hepatic fibrosis and carcinoma. J Gastroenterol Hepatol. (Review of composition, clinical efficacy and mechanism of action of Sho Saiko To; contains 7 herbs, including Bupleurum root, Pinellia tuber, Scutellaria root and Glycyrrhiza root; active components likely to be saikosaponins and the antioxidants, baicalin and baicalein, which resemble silybinin).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including pyrrolizidine alkaloids, germander, celandine, chaparral, Chinese herbs and pennyroyal).
Park GJH, Mann SP, Ngu MC. (2001). Acute hepatitis induced by Shou-Wu-Pian, a herbal product derived from Polygonum multiflorum. J Gastroenterol Hepatol. (46 year old woman developed pruritus and jaundice 2 weeks after starting Shou Wu Pian [bilirubin 12.6 mg/dL, ALT 876 U/L, Alk P 185 U/L], resolving within a month of stopping).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Ernst E. (2002). Adulteration of Chinese herbal medicines with synthetic drugs: a systematic review. J Intern Med. (Systematic review of literature on adulteration of herbal products with conventional medications, in 15 case reports and 2 cases series of 21 patients; included NSAIDs, corticosteroids, benzodiazepines, diuretics and antidiabetic medications, in up to 24% of products).
Ingólfsdóttir K. (2002). Usnic acid. Phytochemistry. (Usnic acid is a lichen metabolite used in creams, toothpaste, deodorants and as a preservative; also has antimicrobial activity and recently promoted as weight loss agent; it is toxic in high doses causing paralysis, ataxia and acidosis).
Whiting PW, Clouston A, Kerlin P. (2002). Black cohosh and other herbal remedies associated with acute hepatitis. Med J Aust. (6 cases of severe hepatitis in patients taking herbal medications including one on black cohosh alone and 5 taking multiple herbals including skullcap [n=3], valerian [n=2], chaparral [n=1] and greater celandine [n=1] for 1 to 14 weeks, presenting with jaundice [bilirubin 9.9-62.7 mg/dL, ALT 1293-3764 U/L, Alk P 80-219 U/L], the 1 on black cohosh alone requiring emergency liver transplantation, the other 5 resolving in 7-25 weeks, 3 treated with prednisone for prolonged cholestasis).
Divinsky M. (2002). Case report: jin bu huan – not so benign herbal medicine. Can Fam Physician. (45 year old woman developed jaundice while taking Jin Bu Huan for anxiety [bilirubin 2.4 mg/dL, ALT 1785 U/L, Alk P 115], with resolution in 6 weeks upon stopping herbal given to her by her visiting Chinese father).
Favreau JT, Ryu ML, Braunstein G, Orshansky G, Park SS, Coody GL, Love LA, Fong TL. (2002). Severe hepatotoxicity associated with the dietary supplement LipoKinetix. Ann Intern Med. (7 patients, 4 women and 3 men, ages 20-32 years, developed symptoms and jaundice [n=5] or liver test abnormalities [n=2], 1-12 weeks after starting LipoKinetix [norephedrine, usnic acid, diiodothyronine, yohimbine, caffeine] for weight loss [peak bilirubin 2.2-14.6 mg/dL, ALT 438-14,150 U/L], resolving in 1 to 3 months of stopping).
(2002). 'Dietary supplement' warning. FDA Consum. (FDA warning letter concerning the toxicity of LipoKinetix, advising against its use).
Lewis JD, Strom BL. (2002). Balancing safety of dietary supplements with the free market. Ann Intern Med. (Editorial on Favreau [2002] regarding LipoKinetix and the regulation of dietary supplements in the US).
McRae CA, Agarwal K, Mutimer D, Bassendine MF. (2002). Hepatitis associated with Chinese herbs. Eur J Gastroenterol Hepatol. (Two patients; 31 year old woman developed jaundice 5 weeks after starting Chinese herbal root teas [bilirubin 8.2 rising to 32.0 mg/dL, ALT 2930 U/L] complicated by hemophagocytosis, but ultimate recovery over next 12 months; 32 year old man took 9 doses of Chinese herbal roots and developed diarrhea and then dark urine [bilirubin 37.8 mg/dL, ALT 242 U/L, INR 8.5], undergoing liver transplantation; explant showed massive necrosis).
Haller CA, Dyer JE, Ko R, Olson KR. (2002). Making a diagnosis of herbal-related toxic hepatitis. West J Med. (42 year old woman took 3 herbals including Jin Bu Huan for insomnia and developed jaundice 10 weeks later [bilirubin 1.2 mg/dL, ALT 3386 U/L, Alk P 100 U/L], resolving in 6 weeks; 39 year old woman took several herbs including chaparral and developed jaundice and confusion [bilirubin 42.7 mg/dL, ALT 349 U/L], followed by liver failure and emergency liver transplantation).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and problems with herbal medications, including lack of standardization and federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Lin TJ, Tsai MS, Chiou NM, Deng JF, Chiu NY. (2002). Hepatotoxicity caused by Breynia officinalis. Vet Hum Toxicol. (Two women ages 43 and 51 years took large amounts of Breynia [one in suicide attempt] and rapidly developed vertigo, vomiting, headache and numbness [peak bilirubin 2.2 and 1.0 mg/dL, ALT 2443 and 2730 U/L, Alk P 103 and 107 U/L], resolving over the next 4 to 6 weeks).
Lin TJ, Su CC, Lan CK, Jiang DD, Tsai JL, Tsai MS. (2003). Acute poisonings with Breynia officinalis—an outbreak of hepatotoxicity. J Toxicol Clin Toxicol. (Breynia officinalis is used in many Chinese medicines, but is also a poison and can be mistaken for other herbs; 19 Chinese villagers drank a soup made from Breynia and developed diarrhea, nausea and liver test abnormalities [peak bilirubin 1.5-2.6 mg/dL, ALT 65-7398 U/L, Alk P 269 U/L], returning to normal in 1-2 months).
Adachi M, Saito H, Kobayashi H, Horie Y, Kato S, Yoshioka M, Ishil H. (2003). Hepatic injury in 12 patients taking the herbal weight loss aids Chaso or Onshido. Ann Intern Med. (12 patients; 10 women and 2 men, ages 25-63 year, developed liver injury 1 to 6 weeks after starting weight loss aids [6 Chaso cases had bilirubin 0.6-19.8 mg/dL, ALT 283-4074 U/L, Alk P 185-768 U/L, 1 liver failure] [6 Onshido cases had bilirubin 0.6-24.2 mg/dL, ALT 634-4868 U/L, Alk P 255-867 U/L], resolving within 2 weeks to 6 months of stopping).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation with discussion of Chinese herbal medicines, including Jin Bu Huan, Ma Huang, Shou Wu Pian, and Sho Saiko To).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications, listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9] and valerian [1]).
Bajaj J, Knox JF, Komorowski R, Saeian K. (2003). The irony of herbal hepatitis: Ma-Huang-induced hepatotoxicity associated with compound heterozygosity for hereditary hemochromatosis. Dig Dis Sci. (44 year old man developed jaundice 4 months after starting Hydroxycut with Ma Huang [bilirubin 3.5 mg/dL, ALT 3600 U/L], resolving in 1 month upon stopping; HFE testing revealed compound heterozygosity: C282Y/H63D).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were attributed to herbal use: 3 Ma Huang, 3 kava, 2 LipoKinetix, 1 chaparral, 1 skullcap and 2 miscellaneous Chinese herbs).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] cases attributed to herbal medications).
Durazo FA, Lassman C, Han SH, Saab S, Lee NP, Kawano M, Saggi B, et al. (2004). Fulminant liver failure due to usnic acid for weight loss. Am J Gastroenterol. (28 year old woman developed nausea and fatigue 2 weeks after starting usnic acid and, despite stopping it, developed jaundice, confusion and hepatic failure requiring liver transplantation [bilirubin 28 mg/dL, ALT 449 U/L, AST 1016 U/L, INR 4.6]; the explant demonstrated massive necrosis).
Willett KL, Roth RA, Walker L. (2004). Workshop overview: Hepatotoxicity assessment for botanical dietary supplements. Toxicol Sci. (Summary of a workshop on the hepatotoxicity of botanicals focusing upon mechanisms of hepatic injury and means of prediction and prevention).
Han D, Matsumaru K, Tettori D, Kaplowitz N. (2004). Usnic acid-induced necrosis of cultured mouse hepatocytes: inhibition of mitochondrial function and oxidative stress. Biochem Pharmacol. (Usnic acid caused necrosis of isolated mouse hepatocytes, probably by uncoupling of electron transport in mitochondria, oxidative stress and depletion of glutathione).
Myers SP, Cheras PA. (2004). The other side of the coin: safety of complementary and alternative medicine. Med J Aust. (Discussion of the safety of complementary and alternative medicines).
Mazzanti G, Battinelli L, Daniele C, Mastroianni CM, Lichtner M, Coletta S, Costantini S. (2004). New case of acute hepatitis following the consumption of Shou Wu Pian, a Chinese herbal product derived from Polygonum multiflorum. Ann Intern Med. (78 year old man developed jaundice 1 month after starting Shou Wu Pian for chronic prostatitis [bilirubin 25.5 mg/dL, ALT 1276 U/L, Alk P 409 U/L], resolving rapidly upon stopping).
Sonmez A, Yilmaz MI, Mas R, Ozcan A, Celasun B, Dogru T, Taslipinar A, Kocar IH. (2005). Subacute cholestatic hepatitis likely related to the use of senna for chronic constipation. Acta Gastroenterol Belg. (77 year old male developed jaundice after taking a senna preparation for constipation for 3 months [bilirubin 4.9 rising to 16.9 mg/dL, ALT 657 U/L, Alk P 160 U/L], resolving within 1 month of stopping the herbal).
Hsu LM, Huang YS, Chang FY, Lee SD. (2005). ‘Fat burner’ herb, usnic acid, induced acute hepatitis in a family. J Gastroenterol Hepatol. (3 sisters with toxicity from herbal “fat burner” consisting of soybean and usnic acid; 36 year old woman had abdominal pain 2 weeks after starting herbal [bilirubin normal, ALT 442 U/L, Alk P 217 U/L], resolving within 6 weeks; 32 year old sister developed jaundice after 4 weeks of use [bilirubin 29 mg/dL, ALT 778 U/L, Alk P 118 U/L, INR 2.6], resolving in 4 months; third sister stopped the herbal after 3 days because of fatigue).
Nam SW, Baek JT, Lee DS, Kang SB, Ahn BM, Chung KW. (2005). A case of acute cholestatic hepatitis associated with the seeds of Psoralea corylifolia (Boh-Gol-Zhee). Clin Toxicol (Phila). (44 year old woman developed nausea followed by jaundice 7 weeks after starting daily ingestion of Psoralea corylifolia tea [bilirubin 7.3 mg/dL, ALT 398 U/L, Alk P 367 U/L], with rapid resolution on stopping).
Panis B, Wong DR, Hooymans PM, De Smet PAMG, Rosias PPR. (2005). Recurrent toxic hepatitis in a Caucasian girl related to the use of Shou-Wu-Pian, a Chinese herbal preparation. J Pediatr Gastroenterol Nutr. (5 year old girl developed jaundice 4 months after being started on Shou Wu Pian [bilirubin 4.9 mg/dL, ALT 1543 U/L, Alk P normal], resolving within 5 weeks and recurring within 4 weeks of restarting, with slower recovery [5 months]).
Casallo Blanco S, Blanco González J, Marcos Sánchez F, Alvarez Cercadillo R, Moreno Palomares M. (2005). Hepatitis tóxica secundaria a hierbas chinas. Gastroenterol Hepatol. (32 year old man developed jaundice a few weeks after starting an unknown Chinese herbal medication [bilirubin 24.5 mg/dL, ALT 2650 U/L, GGT 73 U/L], resolving within 8 weeks of stopping).
López-Briz E, Garrigues-Gil V. (2005). Hepatitis por hierbas chinas. Gastroenterol Hepatol. (Letter in response to Cassalo Blanco [2005] discussing the possible toxic agent in the Chinese herbal preparation).
Arneborn P, Jansson A, Böttiger Y. (2005). Lakartidningen. (20 year old overweight woman developed nausea followed by jaundice 4 weeks after starting a weight loss agent [Termoxical, containing usnic acid] purchased over the Internet [bilirubin 4.9 mg/dL, ALT 1320 U/L, Alk P 198 U/L], resolving within a month of stopping).
Hsu LM, Huang YS, Tsay SH, Chang FY, Lee SD. (2006). Acute hepatitis induced by Chinese hepatoprotective herb, xiao-chai-hu-tang. J Chin Med Assoc. (52 year old woman developed jaundice 1.5 months after starting Xiao Chai Hu Tang, known in Japan as Syo Saiko To [bilirubin 1.9 mg/dL, ALT 2028 U/L, Alk P 213 U/L], resolving within 2 months of stopping).
Yuen MF, Tam S, Fung J, Wong DK, Wong BC, Lai CL. (2006). Traditional Chinese medicine causing hepatotoxicity in patients with chronic hepatitis B infection: a 1-year prospective study. Aliment Pharmacol Ther. (Among 45 patients with chronic hepatitis B hospitalized because of liver dysfunction at Queen Mary Hospital, Hong Kong during 2004, 7 appeared to have liver injury caused by traditional Chinese herbal medications, marked by worsening of liver tests, lack of IgM anti-HBc and low or no detectable HBV DNA; two died and two underwent liver transplantation).
Cárdenas A, Restrepo JC, Sierra F, Correa G. (2006). Acute hepatitis due to shen-min: a herbal product derived from Polygonum multiflorum. J Clin Gastroenterol. (28 year old woman developed fatigue followed by jaundice 8 weeks after starting Shen Min for hair loss [bilirubin 12.3 mg/dL, ALT 2922 U/L, Alk P 153 U/L], resolving within 4 weeks of stopping the herbal).
Sanchez W, Maple JT, Burgart LJ, Kamath PS. (2006). Severe hepatotoxicity associated with use of a dietary supplement containing usnic acid. Mayo Clin Proc. (Two cases: 38 year old woman developed jaundice 3 months after starting 1350 mg daily of UCP-1 [bilirubin 23.0 mg/dL, ALT 1636 U/L, Alk P 195 U/L, protime 22.7 sec], progressing to hepatic failure and successful liver transplantation; 38 year old husband of previous case developed back pain 3 months after starting UCP-1 [bilirubin 0.6 mg/dL, ALT 1462 U/L], with rapid resolution on stopping and normal values 4 months later: Case 1 usnic acid).
Wai CT, Tan BH, Chan CL, Sutedja DS, Lee YM, Khor C, Lim SG. (2007). Drug-induced liver injury at an Asian center: a prospective study. Liver Int. (Prospective survey of drug induced liver injury presenting over 26 months at a single hospital in Singapore identified 31 cases, ages 18-90 years, 55% male, Chinese traditional medicines being implicated in 17 [55%] and Malay agents in 5 cases [16%]; adulterants were found in 9 of 31 tested traditional agents [codeine, corticosteroids, metformin, mercury, nonsteroidal antiinflammatory agents).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal-induced hepatotoxicity, with a review of Chinese herbal medicines such as Chaso, Onshido, Sho Saiko To, Jin Bu Huan, Ma Huang and Shou Wu Pian).
Chitturi S, Farrell GC. (2008). Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol. (Review of hepatotoxicity of herbal medications focusing upon those used for weight loss including nitrosofenfluramine, usnic acid, ephedra, germander, skullcap and green tea).
Foti RS, Dickmann LJ, Davis JA, Greene RJ, Hill JJ, Howard ML, Pearson JT, et al. (2008). Metabolism and related human risk factors for hepatic damage by usnic acid containing nutritional supplements. Xenobiotica. (In vitro analyses of usnic acid and cytochrome P450 enzymes found that it was a potent inhibitor of CYP 2C19 and 2C9, suggesting that it may cause significant drug-herb interactions).
Laird AR, Ramchandani N, deGoma EM, Avula B, Khan IA, Gesundheit N. (2008). Acute hepatitis associated with the use of an herbal supplement(Polygonum multiflorum) mimicking iron-overload syndrome. J Clin Gastroenterol. (35 year old man developed jaundice “several months” after starting “NuHair” [containing Polygonum multiflorum] for hair loss [bilirubin 4.6 rising to 13. 7 mg/dL, ALT 2714 U/L, Alk P 137 U/L, INR 1.3], resolving 4 months after stopping).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, including Camellia sinensis [green tea], Cassia angustifolia [senna], kava, valerian, Rhamnus purshianus [cascara], fitosoja [soy plant], biosoja [soy extract], Aesculus hippocatanum [horse chestnut], chitosan [deacetylated chitin] and Couterea latifloral [Copalchi]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbals and dietary supplements).
Guo L, Shi Q, Fang JL, Mei N, Ali AA, Lewis SM, Leakey JE, Frankos VH. (2008). Review of usnic acid and Usnea barbata toxicity. J Environ Sci Health C Environ Carcinog Ecotoxicol Rev. (Usnea extract has been used in traditional Chinese medicine for centuries as an antimicrobial and for other uses, including in cosmetics, food, toothpaste and mouthwash; in vitro, it has mitochondrial uncoupling properties and was therefore used for weight loss; FDA received 21 adverse event reports including 1 death attributed to dietary supplements containing usnic acid [LipoKinetix and UCP-1] and 12 cases were described in the literature, leading to warnings and recommendations for it to be withdrawn).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and usnic acid).
Cheung WI, Tse ML, Ngan T, Lin J, Lee WSK, Poon WT, Mak TWL, et al. (2009). Liver injury associated with the use of Fructus Psoraleae (Bol-gol-zhee or Bu-gu-zhi) and its related proprietary medicine. Clin Toxicol (Phila). (3 cases of liver injury from dried seeds of P. corylifolia used to treat skin conditions, 2 men and 1 woman, 20-39 years old, taking product for 2-8 weeks, developed jaundice [bilirubin 5.1-5.5 mg/dL, ALT 720-2248 U/L, Alk P 115-177 U/L, INR 1.1-1.2], resolving within 4-9 weeks of stopping; analysis of product revealed psoralen, isopsoralen and coumestrol).
Jacobsen C, Semb S, Kromann-Andersen H. (2009). Ugeskr Laeger. (49 year old developed jaundice 4 weeks after starting daily ingestion of Cascara sagrada for constipation [bilirubin 8.4 rising to 24.6 mg/dL, ALT 944 U/L, ascites], resolving in 4 months).
Wang YP, Shi B, Chen YX, Su J, Jiang CF, Xie WF. (2009). Drug-induced liver disease: an 8 year study of patients from one gastroenterological department. J Dig Dis. (30 patients with drug induced liver disease seen at a single medical university in Shanghai between 2000 and 2008, of which 12 were attributed to Chinese herbs, but specific agents not discussed, 9 were jaundiced, 6 had hepatocellular, 3 cholestatic and 2 mixed patterns of injury).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to a Swedish Registry found multiple agents associated with liver injury including purple cornflower, black cohosh, shark liver oil, valerian, horsetail, ginseng, green tea, ginkgo and aloe vera).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals including usnic acid [2], thermoslim [1], Ma Huang [1], horny goat weed [1], black cohosh [1], hydroxycut [1] and unspecified herbals [4]).
Furukawa M, Kasajima S, Nakamura Y, Shouzushima M, Nagatani N, Takinishi A, Taguchi A, et al. (2010). Toxic hepatitis induced by show-wu-pian, a Chinese herbal preparation. Intern Med. (53 year old Japanese woman developed fatigue after taking Shou Wu Pian for 8 months [bilirubin 1.2 mg/dL, ALT 417 U/L, Alk P 1425 U/L, ANA 1:320], resolving within 2 months of stopping).
Bae SH, Kim DH, Bae YS, Lee KJ, Kim DW, Yoon JB, Hong JH, Kim SH. (2010). Korean J Hepatol. (54 year old Korean woman developed fatigue 1 month after starting Shou Wu [ALT 1136 U/L, Alk P 324 U/L], resolving rapidly but recurring upon restarting).
Chou SL, Chou MY, Kao WF, Yen DH, Yen LY, Huang CI, Lee CH. (2010). Bajiaolian poisoning-a poisoning with high misdiagnostic rate. Am J Emerg Med. (Review of records of 4 poison centers in Taiwan from 1985 to 2003 identified 17 cases of Ba Jiao Lian toxicity, 15 were initially misdiagnosed; presenting with nausea, weakness, confusion, gastrointestinal bleeding, and abnormal liver tests followed by sensory-motor and autonomic neuropathy).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, among the 41 most commonly implicated agents, none were herbals or dietary supplements).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, four cases were attributed to Ayurvedic medications).
Linnebur SA, Rapacchietta OC, Vejar M. Hepatotoxicity associated with chinese skullcap contained in Move Free Advanced dietary supplement: two case reports and review of the literature. Pharmacotherapy 2010; 30(7): 750, 258e-62e. (Two patients developed liver injury within weeks of starting “Move Free Advanced” which contains Chinese skullcap [Scutellaria baicalensis] for arthralgias, resolving upon stopping).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, only one case was attributed to an herbal; hydroxycut).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including one case report attributed to saw palmetto [Lapi 2010]).
Jiménez-Encarnación E, Ríos G, Muñoz-Mirabal A, Vilá LM. (2012). Euforia-induced acute hepatitis in a patient with scleroderma. BMJ Case Rep. (45 year old woman developed jaundice 1 month after starting Euphoria, an herbal mixture whose ingredients included aloe vera, resveratrol, green tea, noni juice and multiple berries [bilirubin 17.7 mg/dL, ALT 837 U/L, Alk P 134 U/L], with slow recovery after stopping).
Weinstein DH, Twaddell WS, Raufman JP, Philosophe B, Mindikoglu AL. (2012). SlimQuick™ - associated hepatotoxicity in a woman with alpha-1 antitrypsin heterozygosity. World J Hepatol. (24 year old woman training for a marathon developed jaundice 4 months after starting SlimQuick [bilirubin 4.0 mg/dL, ALT 2615 U/L, Alk P 200 U/L], was treated with prednisone and had a prompt improvement and was later able to stop corticosteroids without relapse).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Review of HDS associated hepatotoxicity with specific discussion of Ayurvedic, Chinese and Kampo herbal products such as Jin Bu Huan, Ma Huang, Dai-saiko-to).
García Cortés M, Fernández Castañer A. (2013). Rev Esp Enferm Dig. (Information for patients on the hepatotoxicity of herbal medications mentioning the list of botanicals that are prohibited in Spain).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of herbal hepatotoxicity including discussion of Chinese herbals and traditional remedies).
Abdualmjid RJ, Sergi C. (2013). Hepatotoxic botanicals - an evidence-based systematic review. J Pharm Pharm Sci. (Extensive review of the hepatotoxicity of botanicals).
Patel SS, Beer S, Kearney DL, Phillips G, Carter BA. (2013). Green tea extract: a potential cause of acute liver failure. World J Gastroenterol. (16 year old boy developed jaundice 8 weeks after starting a green tea extract for weight loss [bilirubin 14.8 mg/dL, ALT 2984 U/L, Alk P 186 U/L, INR 1.3] with severe course, but ultimate resolution within 6 months).
Teschke R, Wolff A, Frenzel C, Schwarzenboeck A, Schulze J, Eickhoff A. (2014). Drug and herb induced liver injury: Council for International Organizations of Medical Sciences scale for causality assessment. World J Hepatol. (Review of value and relative reliability of RUCAM system of adjudication of causality in drug and herbal induced liver injury).
Dong H, Slain D, Cheng J, Ma W, Liang W. (2014). Eighteen cases of liver injury following ingestion of Polygonum multiflorum. Complement Ther Med. (Between 2005 and 2012, 18 patients with suspected Fo ti [Polygonum multiflorum] hepatotoxicity were seen at a referral hospital in China, ages 19-63 years, 19 men, 10 women, onset after 1 to 120 days [bilirubin 0.6-16.8 mg/dL, ALT 601-4095 U/L, Alk P 89-816 U/L], 12 with jaundice, all hepatocellular, all recovered).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Retrospective analysis of 34 published cases of reexposure after suspected herbal hepatotoxicity suggested that only 21 cases [62%] fulfilled strict criteria of a positive rechallenge as defined by the RUCAM system).
Teschke R, Wolff A, Frenzel C, Schulze J. (2014). Review article: Herbal hepatotoxicity--an update on traditional Chinese medicine preparations. Aliment Pharmacol Ther. (Review and compilation of traditional Chinese herbal medications reported to cause liver injury).
Teschke R. (2014). Traditional Chinese medicine induced liver injury. J Clin Transl Hepatol. (Review and compilation of Chinese traditional medications reported to cause liver injury).
Zhao P, Wang C, Liu W, Wang F. (2014). Acute liver failure associated with traditional Chinese medicine: report of 30 cases from seven tertiary hospitals in China*. Crit Care Med. (Between 2007 and 2013, 30 patients with acute liver failure attributed to traditional Chinese medications were identified at 7 medical centers in China, of whom 18 died [60%] died; specific agents involved not provided).
Melchardt T, Magnes T, Weiss L, Grundbichler M, Strasser M, Hufnagl C, Moik M, Greil R, Egle A. (2014). Liver toxicity during temozolomide chemotherapy caused by Chinese herbs. BMC Complement Altern Med. (56 year old woman with glioblastoma developed liver injury 32 days after starting temozolomide [bilirubin 16.7 mg/dL, ALT 585 U/L, Alk P not given] having also taken a Chinese herbal formula known as Bu Zhong Yi Qi Wan for 2 weeks; after recovery, she was able to restart temozolomide without recurrence of liver injury).
Wang J, Ma Z, Niu M, Zhu Y, Liang Q, Zhao Y, Song J, et al. (2015). Evidence chain-based causality identification in herb-induced liver injury: exemplification of a well-known liver-restorative herb Polygonum multiflorum. Front Med. (Retrospective analysis of 147 cases of liver injury attributed to Polygonum multiflora [He shou wu, Chinese knotweed] using pharmacognosy, phytochemistry and metabolomics correctly identified the liver injury as Heshouwu-induced in most cases).
Lee WJ, Kim HW, Lee HY, Son CG. (2015). Systematic review on herb-induced liver injury in Korea. Food Chem Toxicol. (A systematic review identified 31 reports of HDS induced liver injury in Korea comprising 97 cases due to 21 herbal preparations, Polygonum multiflora [40%] and Dictamnus dasycarpus [37%] being the most frequently implicated herbs).
Zhu Y, Li YG, Wang JB, Liu SH, Wang LF, Zhao YL, Bai YF, et al. (2015). Causes, features, and outcomes of drug-induced liver injury in 69 children from China. Gut Liver. (Among 69 children with drug induced liver injury identified between 2009 and 2012, Western medications accounted for 57% [antibiotics in most] and Chinese patent medicine or decoctions for only 22% [Ephedra, Polygonum, and others]).
Teschke R, Eickhoff A. (2015). Herbal hepatotoxicity in traditional and modern medicine: actual key issues and new encouraging steps. Front Pharmacol. (Review and compilation of herbal products reported to cause liver injury).
Teschke R, Zhang L, Long H, Schwarzenboeck A, Schmidt-Taenzer W, Genthner A, Wolff A, et al. (2015). Traditional Chinese Medicine and herbal hepatotoxicity: a tabular compilation of reported cases. Ann Hepatol. (Review and compilation of traditional Chinese herbal medications reported to cause liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 145 [16%] were attributed to herbal and dietary supplements of which 5 were referred to as Chinese and 3 as Korean herbs or herbal products).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury).
Frenzel C, Teschke R. (2016). Herbal hepatotoxicity: clinical characteristics and listing compilation. Int J Mol Sci. (Review of the challenges in the diagnosis of hepatotoxicity due to herbal products including problems of misidentifications, adulterants, impurities, range of clinical presentations, lack of diagnostic markers, and alternative diagnoses; an extensive compilation of herbs reported to have caused liver injury).
Zhang P, Ye Y, Yang X, Jiao Y. (2016). Systematic review on Chinese herbal medicine induced liver injury. Evid Based Complement Alternat Med. (Systematic review of the literature on liver injury due to traditional Chinese herbal medicines found 17 articles and 114 cases from China, Korea, Japan and the US, but only 54 were judged at least probable with average latency of 30 days, mean ALT 1246 U/L, Alk P 225, bilirubin not given; 81% hepatocellular, 1 fatal and 1 requiring liver transplantation, most frequently implicated agent being He Shou Wu [n=65]).
Teschke R, Larrey D, Melchart D, Danan G. (2016). Traditional Chinese Medicine (TCM) and herbal hepatotoxicity: RUCAM and the role of novel diagnostic biomarkers such as MicroRNAs. Medicines (Basel). (Review of the challenges in assessing causality in cases of liver injury in patients on traditional Chinese medicines and role of the RUCAM in standardization of assessment and use of new biomarkers).
Zhang P, Ye Y, Yang X, Jiao Y. (2016). Systematic review on Chinese herbal medicine induced liver injury. Evid Based Complement Alternat Med. (Systematic review of the literature on hepatotoxicity of traditional Chinese medicines identified 17 relevant publications with a total of 114 cases; 83 from China, 26 Korea, 4 US and 1 Japan; 4 single herbs, 21 patent medicines and 4 decoctions; mostly frequently implicated agent being He Shou Wu [65]).
Melchart D, Hager S, Dai J, Weidenhammer W. (2016). Quality control and complication screening programme of Chinese medicinal drugs at the First German Hospital of Traditional Chinese Medicine - a retrospective analysis. Forsch Komplementmed. (Among 994 patients treated with Chinese herbal medications, 6 developed elevations in serum ALT [31-361 U/L] or AST [39-326 U/L], but other reasons for the elevations were found in most).
Melchart D, Hager S, Albrecht S, Dai J, Weidenhammer W, Teschke R. (2017). Herbal Traditional Chinese Medicine and suspected liver injury: a prospective study. World J Hepatol. (Among 21,470 patients admitted to a German hospital for Traditional Chinese Medicine between 1994 and 2015, 870 developed elevations in ALT levels during the admission, but only 26 were greater than 5 times ULN, of whom only 8 were consider probably due to herbal medicine).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products).
Jing J, Teschke R. (2018). Traditional Chinese Medicine and herb-induced liver injury: comparison with drug-induced liver injury. J Clin Transl Hepatol. (Comparison of general clinical features of cases of drug induced vs herbal and dietary supplement induced liver injury in the published literature suggested that injury of herbal products was more likely to be hepatocellular and was overall less severe than cases from conventional medications).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being Green tea [n=8] and Herbalife products [n=6], while none were attributed to Aloe vera).
Liu Z, He X, Wang L, Zhang Y, Hai Y, Gao R. (2019). Chinese herbal medicine hepatotoxicity: the evaluation and recognization based on large-scale evidence database. Curr Drug Metab. (Review of the challenges of establishing causality in cases of suspected drug induced liver injury from Traditional Chinese Medicine).
Li A, Gao M, Zhao N, Li P, Zhu J, Li W. (2019). Acute liver failure associated with Fructus Psoraleae: a case report and literature review. BMC Complement Altern Med. (53 year old woman developed jaundice 7 months after starting Qubaibabuqi tablets [a traditional Uyghur medicine] for vitiligo [bilirubin 1.6 mg/dL, ALT 804 U/L, Alk P not given], with rapid progression of liver failure and death within 4 days; the implicated ingredient being seeds of Psoraleae corylifolia which has been implicated in 6 non-fatal of acute hepatitis in the literature).
Chow HC, So TH, Choi HCW, Lam KO. (2019). Literature review of Traditional Chinese Medicine herbs-induced liver injury from an oncological perspective with RUCAM. Integr Cancer Ther. (Systematic review of the literature on Tradition Chinese Medicine induced liver injury identified 50 publications and 194 causality confirmed cases including 80 due to Polygonum multiflorum [Fo Ti], 28 to Camellia sinensus [green tea], 7 to Dictamnus dasycarpus [Bai Xian Pi], 4 to Gynura segetum, 3 to Lycopodium serratum, 2 to Pueraria lobata and 1 to each of 14 others).
Ghorbani A, Zarvandi M, Rakhshandeh H. (2019). A randomized controlled trial of a herbal compound for improving metabolic parameters in diabetic patients with uncontrolled dyslipidemia. Endocr Metab Immune Disord Drug Targets. (Among 50 patients with diabetes and dyslipidemia treated with a multiingredient herbal supplement [with aloe vera, fenugreek, black seed, psyllium, garlic and milk thistle] or placebo twice daily for 12 weeks, cholesterol, triglycerides, and HgA1c levels improved, and there was “no unwarranted effect” on serum creatinine, ALT or AST).
Cai P, Qiu H, Qi F, Zhang X. (2019). The toxicity and safety of Traditional Chinese Medicines: Please treat with rationality. Biosci Trends. (Commentary on issue of hepatotoxicity of Traditional Chinese Medicine which can be avoided by use of appropriate dosing of agents for their intended use only, not given chronically as a “dietary supplement” and with appropriate monitoring and caution).
Liu Y, Zhan SP, Song L, Chen Y, Jia YT, Liu F, Sun FJ, Wang Q, Xia PY. (2020). Drug-induced liver injury: clinical and etiologic features at a large tertiary teaching hospital in China. Med Sci Monit. (Among 1811 patients with drug induced liver injury seen at a large referral hospital between 2011 and 2016, 462 [42%] were due to conventional medications, 391 [36%] to herbal products and 189 [17%] to both; 172 [16%] were due to antibiotics and 198 [18%] to Traditional Chinese Medicines).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being Green tea [n=7], Herbalife products [n=5] and Garcinia [n=3]).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91, Fo ti or Polygonium multiflorum], Green tea [90], Herbalife products [64], Kava [62], Greater celandine [48], Germander [35], Skullcap [35], Kratom [33], Gynura segetum [29], Garcinia cambogia [29], Ma huang [27], Chaparral [26], Senna [25], Aloe vera [22], and Jin Bu Huan [Lycopodium serratum, 19]).